# Oxacillin

## OVERVIEW

### Introduction

Oxacillin is a parenteral, second generation penicillin antibiotic that is used to treat moderate-to-severe, penicillinase-resistant staphylococcal infections. Oxacillin has been linked to rare instances of clinically apparent, idiosyncratic liver injury, but it more commonly causes transient elevations in serum aminotransferases without jaundice.

### Background

Oxacillin (ox" a sil' in) is a second generation penicillin that is highly resistant to inactivation by penicillinases and is used to treat moderate-to-severe bacterial infections caused by penicillinase-producing bacteria, particularly staphylococcal infections. Oxacillin was approved for use in the United States in the early 1960s and is still in common use. Oxacillin is indicated for moderate-to-severe bacterial infections caused by sensitive agents including acute or chronic osteomyelitis and valvular endocarditis. Currently, oxacillin is available in parenteral preparations in several generic formulations. The recommended dose is 250 or 500 mg intramuscularly or intravenously every 4 to 6 hours daily for up to 1 to 8 weeks depending upon the type and severity of infection. Oral formulations of oxacillin are no longer available. Common side effects of oxacillin include fatigue, anxiety, dizziness, diarrhea, nausea, fever, liver test abnormalities and hypersensitivity reactions. Rare but potentially severe adverse events include anaphylaxis, Clostridioides difficile associated colitis and neutropenia.

### Hepatotoxicity

Oxacillin has been linked to two forms of hepatotoxicity, first an acute and transient elevation in serum aminotransferase levels occurring with high doses of intravenous therapy; and second, a more prolonged, usually cholestatic, idiosyncratic liver injury that is similar to the hepatotoxicity of other second-generation penicillins such as dicloxacillin, flucloxacillin, and nafcillin.

High doses of intravenous oxacillin are commonly accompanied by elevations in serum ALT in the range of 2 to 20 times the upper limit of normal arising after 1 to 3 weeks of therapy. Alkaline phosphatase levels are only minimally elevated and bilirubin levels may increase but rarely rise above the upper limit of normal (ULN). Jaundice does not occur. Fever and nonspecific symptoms of abdominal pain and nausea can occur, but are often absent. Eosinophilia is present in some patients, but rash and arthralgias are uncommon. Serum aminotransferase levels rapidly fall into the normal range (in 1 to 2 weeks) with discontinuation of oxacillin or switch to oral forms of penicillinase-resistant penicillins. There appears to be no cross reactivity of this response with the natural penicillins or even nafcillin or dicloxacillin. Intravenous carbenicillin can cause a similar syndrome but is no longer available in the United States. This hepatotoxicity may be more common in persons with human immunodeficiency virus (HIV) infection than those who are not infected.

In addition to the common syndrome of asymptomatic serum aminotransferase elevations during high dose intravenous therapy, oxacillin can also but rarely lead to a more prolonged usually cholestatic hepatitis that appears 1 to 6 weeks after starting therapy and may persist for weeks to months. Immunoallergic features of rash, fever and eosinophilia can occur, but are not prominent. Autoantibodies are not found. The liver injury can be prolonged, but generally resolves within 1 to 2 months of onset. Liver biopsy generally shows a cholestatic hepatitis with mixed inflammatory infiltrates. This form of idiosyncratic liver injury is similar to that described with dicloxacillin and other second generation penicillins such as flucloxacillin, which was never approved for use in the United States, and cloxacillin, which is no longer available.

Likelihood score: A (well established cause of two forms of clinically apparent liver injury)

### Mechanism of Injury

The cause of ALT elevations during high dose oxacillin therapy is not known, but may be due to a direct but mild injury to the liver. Fever is common, and eosinophilia and rash can occur. Liver biopsy during these episodes generally shows mild, focal cell injury. The idiosyncratic reaction to oxacillin (and other related penicillins) is rarely accompanied by signs of hypersensitivity or allergy, but has some characteristics that suggest such a mechanism, such as the rapid reappearance of injury with reexposure, and an association with a history of penicillin allergy. Too few cases of oxacillin cholestatic injury have been reported to comment on possible HLA associations, such as the link to HLA-B*57:01 which has been made to flucloxacillin.

### Outcome and Management

The serum aminotransferase elevations that appear during high dose intravenous therapy with oxacillin are usually benign, asymptomatic and resolve rapidly with stopping therapy or switching to other forms of penicillinase-resistant penicillins. The cholestatic hepatitis that occurs very rarely can be symptomatic and prolonged, but has not been linked to acute, liver failure, chronic or permanent injury, or vanishing bile duct syndrome. Prednisone has been used to treat the cholestatic liver injury, but its effects are unclear while its side effects can be serious. Patients should be told to avoid reexposure to the penicillinase-resistant penicillins, including nafcillin and dicloxacillin.

Drug Class: Penicillin (Penicillinase-Resistant)

## CASE REPORT

### Case 1. Elevated aminotransferase levels during intravenous oxacillin therapy.(1)

A 52 year old man with multiple medical problems was treated with intravenous oxacillin for suspected osteomyelitis and was found to have elevations in ALT (104 U/L) and AST (82 U/L), with normal alkaline phosphatase and bilirubin levels when tested 7 days later. He had no symptoms that could be attributed to liver injury. Oxacillin was continued, but ALT levels continued to rise. Oxacillin was stopped after 6 weeks. Serum aminotransferase levels promptly fell and were near normal when he was discharged 2 weeks later. This patient also had multiple other medical problems including hypertension, diabetes, chronic hepatitis C, gastrointestinal reflux, chronic obstructive lung disease, depression and chronic radiculopathy for which he took many medications, none of which had been changed recently.

#### Key Points

Medication: | Oxacillin
Pattern: | Hepatocellular (ALT elevations only)
Severity: | 1+ (aminotransferase elevations without jaundice)
Latency: | One week
Recovery: | Almost complete within 2 weeks of discontinuation
Other medications: | Amlodipine, metoprolol, insulin, lansoprazole, levothyroxine, gabapentin, trimethoprim-sulfamethoxazole, diazepam, cyclobenzaprine, docusate, senna, iron, naproxen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
- 1 week | | 16 | 54 | 0.7 | Admitted with osteomyelitis
0 | Oxacillin started: 2 grams iv every 6 hours
7 days | | 104 | 79 | 0.6
38 days | | 108 | 92 | 0.7
40 days | | 306 | 98 | 0.7
41 days | Oxacillin stopped
43 days | 2 days | 318 | 99 | 0.7
46 days | 5 days | 85
49 days | 9 days | 57 | 85 | 0.6
52 days | 12 days | 59 | 80 | 0.6
Normal Values | | <40 | <115 | <1.2

#### Comment

Oxacillin is well known to cause serum ALT elevations when given in high doses intravenously. The elevations are usually mild to moderate (<20 fold elevated) and appear after 4 to 20 days. Most patients are asymptomatic, but complaints of abdominal discomfort or fever may arise. Alkaline phosphatase and bilirubin levels usually remain normal. Patients usually tolerate other intravenous antibiotics (including nafcillin) without recurrence and the injury is self-limited, not leading to jaundice or severe liver disease even if oxacillin is continued. The presence of an underlying chronic hepatitis C complicates the interpretation of this case and many of the cases in the literature. However, serum ALT levels were normal before oxacillin was started and returned towards baseline once it was stopped, making it likely that the changes were due to the drug.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Oxacillin – Generic

DRUG CLASS

Penicillin (Penicillinase-Resistant)

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Oxacillin | 66-79-5 | C19-H19-N3-O5-S | SID: 134972946

CITED REFERENCES

1 Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, et al; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. 18955056

## ANNOTATED BIBLIOGRAPHY

References updated: 09 August 2026

Abbreviations used: ULN, upper limit of normal

Zimmerman HJ. Synthetic penicillins. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 596-8. (Expert review of penicillins and liver injury published in 1999).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics mentions that liver injury from the penicillins is very rare, and is usually cholestatic for the oxypenicillins such as dicloxacillin and cloxacillin).
MacDougall C. Penicillins, cephalosporins, and other β-lactam antibiotics. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1023-38. (Textbook of pharmacology and therapeutics).
Freedman MA. Oxacillin—apparent hematologic and hepatic toxicity. Rocky Mt Med J 1965; 62: 34-6. (33 year old woman developed AST elevations to ~220 U/L, atypical lymphocytosis and eosinophilia after 2.5 months of high dose oral oxacillin, complicated by bone marrow suppression and breakthrough in chronic osteomyelitis). 14224480
Pas AT, Quinn EL. Cholestatic hepatitis following the administration of sodium oxacillin. JAMA 1965; 191: 674-5. 14242432 (65 year old woman developed itching and jaundice the week after stopping a 4 week course of oral oxacillin [bilirubin 2.2 mg/dL, Alk P ~twice elevated, AST 76 U/L], resolving within 8 weeks).
Dismukes WE. Oxacillin-induced hepatic dysfunction. JAMA 1973; 226: 861-3. (3 cases of ALT elevations, fever and nausea arising 11-24 days after starting high dose intravenous oxacillin therapy, with rapid reversal on stopping). 4800332
Klein I, Tobias H. Oxacillin-associated hepatitis. Am J Gastroenterol 1976; 65: 546. (23 year old male injection drug user developed ALT elevations [~275 U/L] without symptoms or change in bilirubin or Alk P after 10 days of intravenous oxacillin [16 g/day), with rapid resolution [<1 week] on stopping). 961686
Olans RN, Weiner LB. Reversible oxacillin hepatotoxicity. J Pediatr 1976; 89: 835-8. (8 instances of ALT elevations [peak values 31-1359 U/L] without jaundice [2 had eosinophilia] after 8-25 days of intravenous oxacillin in children or young adults, with rapid resolution; no recurrence when switched to nafcillin). 978335
Bruckstein AH, Attia AA. Oxacillin hepatitis. Two patients with liver biopsy, and review of the literature. Am J Med 1978; 64: 519-22. (Two injection drug users treated with high dose oxacillin [12-16 g/day] for endocarditis developed increased AST levels [10-40 times ULN], with mild symptoms but no change in Alk P or bilirubin and nonspecific biopsy findings, arising after 2-3 weeks and resolving rapidly with stopping). 637061
Goldstein LI, Granoff M, Waisman J. Hepatic injury due to oxacillin administration. Am J Gastroenterol 1978; 70: 171-4. (21 year old male injection drug used developed aminotransferase elevations [ALT 806 U/L, AST 388 U/L, 15% eosinophils] 20 days after starting intravenous oxacillin [12 g/day], with biopsy showing hepatitis, rapid recovery). 717369
Onorato IM, Axelrod JL. Hepatitis from intravenous high-dose oxacillin therapy: findings in an adult inpatient population. Ann Intern Med 1978; 89: 497-500. (Review of experience with high dose oxacillin revealed 8 cases of liver injury, rising 3-19 days after start of therapy with fever and mild GI symptoms, ALT 2 to 15 times ULN, Alk P minimally increased, and no jaundice; resolving in 1 week; compared to control group, a history of penicillin allergy was given in 3 cases, but not controls). 697229
D'Angelo LJ. Oxacillin and hepatotoxicity. Ann Intern Med 1979; 90: 442. (Letter commenting on article by Onorato & Axelrod, without new data). 426429
Taylor C, Corrigan K, Steen S, Craig C. Oxacillin and hepatitis. Ann Intern Med 1979; 90: 857-8. (Letter in response to Onorato & Axelrod describing 24 year old man who developed ALT elevations [226 U/], with rash and eosinophilia after 27 days of intravenous oxacillin therapy [8 g/day], rapidly resolving upon switching to nafcillin). 434706
Pollock AA, Berger SA, Simberkoff MS, Rahal JJ Jr. Hepatitis associated with high-dose oxacillin therapy. Arch Intern Med 1978; 138: 915-7. (Prospective study of liver tests in 41 patients during intravenous oxacillin therapy; 15 had ALT elevations, but only 5 were attributed to oxacillin, 12-23 g/day arising 5-24 days after starting, peak ALT values 5-20 times ULN, mild Alk P elevation in 4, but normal bilirubin in all, and resolution in 4-16 days of stopping; no eosinophilia, fever or symptoms). 646563
Halloran TJ, Clague MD. Hepatitis associated with high-dose oxacillin therapy. Arch Intern Med 1979; 139: 376-7. (Letter in response to Pollock [1978] describing 16 year old girl with no history of injection drug use who developed AST elevations [peak 140 U/L], starting after 9 days of intravenous oxacillin, rapid resolution upon stopping). 426588
Nahata MC, DeBolt SL, Powell DA. Adverse effects of methicillin, nafcillin and oxacillin in pediatric patients. Dev Pharmacol Ther 1982; 4: 117-23. (Prospective study of children treated with intravenous methicillin [28], nafcillin [32] or oxacillin [8]; minimal ALT elevations occurred in 1 on nafcillin and 1 on oxacillin; no jaundice). 7172968
Miller WI, Souney PF, Chang JT. Hepatic dysfunction following nafcillin and cephalothin therapy in a patient with a history of oxacillin hepatitis. Clin Pharm 1983; 2: 465-8. (Mild ALT elevations after 13 days of high dose oxacillin [18 g/day], similar increase after nafcillin and again with cephalosporin in a male injection drug user with probable chronic hepatitis C, which might have accounted for ALT fluctuations). 6627877
Tauris P, Jørgensen NF, Petersen CM, Albertsen K. Prolonged severe cholestasis induced by oxacillin derivatives. A report on two cases. Acta Med Scand 1985; 217: 567-9. (2 case reports: 65 year old man with osteomyelitis developed jaundice and pruritus 6 weeks after starting flucloxacillin [bilirubin ~10 mg/dL, AST 1.5 times ULN, Alk P 3 times ULN], biopsy showing cholestasis, resolving within 8 weeks of stopping; 21 year old man with osteomyelitis developed jaundice 9 weeks after starting dicloxacillin [bilirubin ~4 mg/dL, AST 119 U/L, Alk P 814 U/L], resolving within 6 weeks of stopping). 4025011
Saliba B, Herbert PN. Oxacillin hepatotoxicity in HIV-infected patients. Ann Intern Med 1994; 120: 1048. (Retrospective review found that 81% [9/11] of HIV-positive, but only 4.5% [3/66] of HIV-negative patients receiving iv oxacillin for more than 10 days developed ALT or AST >3 fold elevated). 8185140
Al-Homaidhi H, Abdel-Haq NM, El-Baba M, Asmar BI. Severe hepatitis associated with oxacillin therapy. South Med J 2002; 95: 650-2. (6 year old girl developed fever, abdominal pain and marked ALT elevation [peak 2,257 U/L] with normal Alk P and bilirubin [0.3 mg/dL] after 14 days of intravenous oxacillin, resolving within 3 weeks of stopping). 12081223
Trevenzoli M, Cattelan AM, Mencarelli R, Meneghetti F. Severe hepatitis associated with oxacillin therapy. South Med J 2003; 96: 324-5. (Letter in response to Al-Homaidhi [2002] describing 33 year old who developed liver injury [bilirubin 1.8 mg/dL, ALT 2440 U/L, Alk P 103 U/L] weeks after receiving a 4 day course of amoxicillin/clavulanate [not oxacillin as suggested by the title]). 12659378
Ibáñez L, Pérez E, Vidal X, Laporte JR; Grup d'Estudi Multicènteric d'Hepatotoxicitat Aguda de Barcelona (GEMHAB). Prospective surveillance of acute serious liver disease unrelated to infectious, obstructive, or metabolic diseases: epidemiological and clinical features, and exposure to drugs. J Hepatol 2002; 37: 592-600. (Survey of 107 cases of acute serious liver disease, not due to viruses, found no instances of drug induced liver injury due to penicillinase-resistant penicillins). 12399224
Maraqa NF, Gomez MM, Rathore MH, Alvarez AM. Higher occurrence of hepatotoxicity and rash in patients treated with oxacillin, compared with those treated with nafcillin and other commonly used antimicrobials. Clin Infect Dis 2002; 34: 50-4. (Retrospective analysis of laboratory tests from 222 children receiving outpatient parenteral oxacillin, nafcillin, clindamycin or other antibiotics found 12 cases of anicteric and self-limited hepatotoxicity, 9 [22%] from oxacillin, all hepatocellular with normal bilirubin, onset in 6-43 days, resolution in 1-3 weeks; none to nafcillin; 1 clindamycin, 1 ceftriaxone and 1 ampicillin/sulbactam/gentamicin). 11731945
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Analysis of all fatal adverse drug event reports of liver injury in Sweden between 1966 and 2002, found 103 cases; most common causes were halothane [n=16], acetaminophen [14], flucloxacillin [9], and TMP-SMZ [6]). 16165719
Hussaini SH, O'Brien CS, Despott EJ, Dalton HR. Antibiotic therapy: a major cause of drug-induced jaundice in southwest England. Eur J Gastroenterol Hepatol 2007; 19: 15-20. (Review of causes of non-obstructive jaundice in 347 patients presenting between 1998 and 2004 at a single UK center, 28 were thought to be drug induced liver injury [8.1%] and antibiotics were the most common cause, 32% amoxicillin/clavulanate, 25% flucloxacillin, 18% other). 17206072
Lee CY, Chen PY, Huang FL, Chi CS. Reversible oxacillin-associated hepatitis in a 9-month old boy. J Ped Child Health 2008; 44: 146-8. (9 month old boy given intravenous oxacillin for septic arthritis for 8 days when he developed lethargy and marked elevations in ALT [1568 U/L], with normal Alk P and bilirubin and resolving within 10 days of switching to teicoplanin). 18307421
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug- Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, antimicrobials accounted for 45% of cases with 23 single agent cases due to amoxicillin/clavulanate, 13 nitrofurantoin, 10 fluoroquinolones, 9 macrolides, 9 sulfonamides, 5 cephalosporins, 3 oxacillin, 2 doxycycline, 2 amoxicillin, and one each for gentamicin, imipenem, and clindamycin, but none from dicloxacillin or nafcillin). 18955056
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; leading causes were antituberculosis agents [58%], anticonvulsants [11%] and NSAIDs [2%]; specific antibiotic agents included sulfamethoxazole/ trimethoprim [2%] and amoxicillin-clavulanate [1%]). 20648003
Ferrajolo C, Capuano A, Verhamme KMC, Schuemie M, Rossi F, Stricker BH, Sturkenboom CJM. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. BJCP 2010; 70: 721-8. (Among 624,673 adverse drug reports in children in a worldwide pharmacovigilance database, 6595 [1%] were for hepatic injury and antibacterials accounted for 11%, those with the highest adjusted odds ratios being aztreonam, erythromycin, ceftriaxone and minocycline; no mention of penicillins). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 66 due to antimicrobial agents, but none were attributed to a penicillinase-resistant penicillin). 20949552
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: pathomechanisms and clinical data. Infection 2010; 38: 3-11. (Review of hepatotoxicity of antibiotics, mentions that cholestatic hepatitis has been reported with many beta-lactams and beta-lactamases inhibitors). 20107858
Monshi MM, Faulkner L, Gibson A, Jenkins RE, Farrell J, Earnshaw CJ, Alfirevic A, et al. Human leukocyte antigen (HLA)-B*57:01-restricted activation of drug-specific T cells provides the immunological basis for flucloxacillin-induced liver injury. Hepatology 2013; 57: 727-39. (T cells from persons with HLA-B*57:01 were activated when exposed to dendritic cells presenting flucloxacillin bound to albumin, and were similarly activated by oxacillin, cloxacillin and dicloxacillin). 22987284
Sistanizad M, Peterson GM. Drug-induced liver injury in the Australian setting. J Clin Pharm Ther 2013; 38: 115-20. (Among 17 persons with suspected drug induced liver injury seen over at 12 month period at a referral hospital in Tasmania, 11 were attributed to antibiotics including 4 to flucloxacillin, 2 amoxicillin with clavulanate, 2 amoxicillin, and 1 each to rifampin, moxifloxacin and ciprofloxacin). 23350857
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, Presentation and Outcomes in Patients with Drug-Induced Liver Injury in the General Population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 36 [37%] due to antibiotics and specifically dicloxacillin in 1 of 22,320 patients treated and cloxacillin in 1 of 3659 patients treated). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, Chirino RA, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, of which 37 [19%] were attributed to antimicrobials, but none to penicillinase-resistant penicillins such as oxacillin or dicloxacillin). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 cases [36%] were attributed to antibiotics 3 of which were due to oxacillin, all being self-limited episodes of aminotransferase elevations without jaundice; no instances of dicloxacillin or nafcillin associated liver injury). 25754159
Cirulli ET, Nicoletti P, Abramson K, Andrade RJ, Bjornsson ES, Chalasani N, Fontana RJ, et al; Drug-Induced Liver Injury Network (DILIN) investigators; International DILI consortium (iDILIC). A missense variant in PTPN22 is a risk factor for drug-induced liver injury. Gastroenterology 2019; 156: 1707-1716.e2. 30664875 (Genome wide association studies on 2048 patients with drug-induced liver injury and 12,439 controls identified a variant in PTPN22 which was highly associated with liver injury, allele frequency being 0.12 among cases and 0.08 among controls with highest association in Northern Europeans and in cases of amoxicillin-clavulanate, PTPN22 being a cellular kinase involved in modulation of immune reactions).
Nicoletti P, Aithal GP, Chamberlain TC, Coulthard S, Alshabeeb M, Grove JI, Andrade RJ, et al; International Drug-Induced Liver Injury Consortium (iDILIC). Drug-induced liver injury due to flucloxacillin: relevance of multiple human leukocyte antigen alleles. Clin Pharmacol Ther. 2019;106:245-253. (Among 197 patients with flucloxacillin-induced liver injury, genome wide association studies demonstrated a strong association with HLA-B*57:01 compared to controls [AF .42 vs .04], but the allele was not found increased among 6 patients with oxacillin-, dicloxacillin-. or cloxacillin-induced liver injury or in 15 with amoxicillin-induced liver injury). 30661239
Hashim A, Barnabas A, Miquel R, Agarwal K. Successful liver transplantation for drug-induced vanishing bile duct syndrome. BMJ Case Rep. 2020;13:e233052. (63 year-old-woman developed jaundice 4 days after finishing a 10-day course of flucloxacillin for a skin infection [bilirubin 29.3 mg/dL, ALT 60 U/L, Alk P 287 U/L] with progressive cholestasis leading to liver transplantation 6 months after initial onset). 31948982
Timbrook TT, McKay L, Sutton JD, Spivak ES. Disproportionality analysis of safety with nafcillin and oxacillin with the FDA Adverse Event Reporting System (FAERS). Antimicrob Agents Chemother. 2020;64:e01818-19. (Analysis of the FDA’s Adverse Event Reporting System [FAERS] between 2003 and 2018 found a similar proportion of hepatotoxicity cases attributed to oxacillin [20 of 289 total adverse event reports] compared to nafcillin [18 of 331] while reports of acute renal failure were less frequent with oxacillin vs nafcillin [13 vs 52]). 31844017
Khatib S, Sabobeh T, Bock MD, Masoud A, Alallaf J. Nafcillin-induced hepatic injury: a case report and literature review. Cureus. 2021;13:e12817. (66 year old man with toe infection developed jaundice 9 days after finishing an 18-day course of iv nafcillin [bilirubin 6.2 mg/dL, ALT 415 U/L, Alk P 506 U/L] which worsened for a few days but then gradually resolved completely without corticosteroids or other specific therapy). 33628683
Angheleanu R, Swart JN. Flucloxacillin-induced liver injury in elderly patient. BMJ Case Rep. 2021;14:e241071. (A 91-year-old woman developed dark urine, jaundice, and confusion 3 to 4 weeks after a 7- and then a 5-day course of flucloxacillin for cellulitis [bilirubin 14 mg/dL, ALT 116 U/L, Alk P 1083 U/L, INR 1.5] but ultimately improved with supportive therapy only and her condition “settled slowly” for the next 4 weeks). 33958360
Faragalla K, Lau H, Wang HL, Liu J. Cloxacillin-induced acute vanishing bile duct syndrome: a case study and literature review. Br J Clin Pharmacol. 2022;88:4633-4638. (66-year-old woman with cerebral vascular disease developed weakness and progressive jaundice a week after finishing a 6-week course of cloxacillin and sought medical care 2 weeks later [bilirubin of 44 mg/dL, ALT 877 U/L, Alk P 4279 U/L, eosinophils 1,200/μL], with persistence of jaundice and liver biopsy showing ductopenia was referred for liver transplant but died of complications before surgery). 35730139
Coombs S, Pittet LF, Tang K, Gwee A. Incidence and predisposing factors for flucloxacillin-related hepatotoxicity in children. J Antimicrob Chemother. 2023;78:2667-2671. (Among 393 children treated with iv flucloxacillin who had liver tests taken before and after therapy, 66 developed “hepatotoxicity” which was mostly isolated elevations in GGT, ALT, AST, or bilirubin with no serious outcomes or persistent injury). 37699070
Warring SR, Biggs JM, Morgan JA, Parbuoni KA. Comparison of adverse effect profiles of nafcillin and oxacillin in pediatric patients. J Pediatr Pharmacol Ther. 2024;29:645-649. (Among 17 children receiving iv nafcillin and 36 iv oxacillin for at least 48 hours at a single referral hospital, liver test abnormalities arose at equal rates [17%] and [18%] while creatinine elevations were numerically less frequent with nafcillin [21% vs 30%]). 39659857
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1,739 hospitalizations for acute liver injury suspected to be due to outpatient prescribed medications none of which were attributed to a penicillinase-resistant penicillin). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 468 cases of drug-induced liver injury enrolled in a prospective Latin American database only 1 was attributed to oxacillin and none to other penicillinase-resistant penicillins: personal communication). 38992407
Huang YT, Huang YM, Lee NC, Lee PI, Ho YF. Medication hazards and outcome patterns of pediatric drug-associated liver injury in Taiwan: an analysis of 1998-2017 spontaneous adverse drug reaction reports. Drugs Real World Outcomes. 2025;12:105-114. (Among 16,673 spontaneous reports of adverse drug reactions in children made to a Taiwanese national registry between 1998 and 2017, 484 were liver related and attributed to 193 different drugs the most frequent implicated being oxacillin [25 reports] followed by methotrexate [20], phenobarbital [13], phenytoin [10] and valproate [10]). 39775441
Nibell O, Björk J, Nilsson A, Jacobsson G, Inghammar M. The risk of drug-induced liver injury associated with flucloxacillin: a nationwide, entropy-balanced cohort study. Clin Microbiol Infect. 2025;31:600-606. (Analysis of Swedish national registries of drug prescriptions and cases of drug induced liver disease occurring within 45 days of the prescription between 2006 and 2018 yielded rough estimates for incidence of liver injury as 1 in 525 cases per person exposed to flucloxacillin [219 cases in 1,129,091 individuals] vs 1 in 5,250 exposed to clindamycin [9 cases in 471,666]). 39716553
Perez AD, Brenner AL, Pieta E, Harrison R, Sultan S, Ponder MG, Daniels L. Incidence of acute kidney injury with the use of nafcillin versus oxacillin. Pharmacotherapy. 2026;46:e70145. (Among 171 hospitalized patients treated with nafcillin between 2020 and 2024 vs 467 with oxacillin between 2015 and 2020, acute renal injury occurred more frequently with nafcillin vs oxacillin [33% vs 20%], in-hospital mortality was greater [13% vs 6%], and liver test elevations above 3 times ULN more common [17% vs 9%]: details of liver tests not provided). 41998805

## OTHER REFERENCE LINKS

1. Recent References on Oxacillin: from PubMed.gov (http://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=oxacillin/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Oxacillin: from ClinicalTrials.gov (http://clinicaltrials.gov/ct2/results?term=oxacillin)